# Liraglutide

## OVERVIEW

### Introduction

Liraglutide is a recombinant DNA produced polypeptide analogue of human glucagon-like peptide-1 (GLP-1) which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other antidiabetic agents. There have been no published reports of hepatotoxicity attributed to liraglutide therapy.

### Background

Liraglutide (lir" a gloo' tide) is a glucagon-like peptide-1 (GLP-1) analogue that acts like the native gastrointestinal hormone (incretin) to increase insulin secretion. Liraglutide reproduces the activity of GLP-1, binding to specific receptors on pancreatic beta cells and increasing insulin secretion, which can lead to improvement of glycemic control in patients with type 2 diabetes. Liraglutide is a recombinant DNA produced polypeptide that shares 97% homology to endogenous human GLP-1(7-37), which represents 20% of circulating GLP-1 activity in serum. Unlike GPL-1(7-37), however, liraglutide is resistant to DPP-4 degradation and thus has a prolonged duration of activity. Liraglutide, like other GLP-1 analogues, must be given parenterally. Liraglutide was approved for use in the United States in 2010 and current indications are for management of glycemic control in adults with type 2 diabetes in combination with diet and exercise, with or without other oral hypoglycemic agents. Liraglutide is available under the brand name Victoza in solution for subcutaneous injection in prefilled multidose pens (6 mg/mL). The typical initial dose is 0.6 mg once daily, which can be increased to a maximum of 1.8 mg daily. Liraglutide is generally well tolerated, but side effects can be dose limiting and include nausea, vomiting, diarrhea, dizziness, headache, fatigue and rash.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were no more common with liraglutide therapy than with placebo or comparator agents, and no instances of clinically apparent liver injury were reported. Since licensure, there has been a single case report of autoimmune hepatitis arising in a patient taking liraglutide. She did not improve with stopping liraglutide and ultimately required long term corticosteroid therapy, suggesting that the autoimmune hepatitis was independent of the drug therapy or that liraglutide triggered an underlying condition. Other cases of hepatotoxicity due to liraglutide have not been published and the product label does not list liver injury as an adverse event. Thus, liver injury due to liraglutide must be quite rare.

### Mechanism of Injury

Liraglutide is a polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential. Liraglutide acts through the incretin pathway to affect glucose metabolism and, thus, is often grouped with other incretin-based antidiabetic mediations such as the DPP-4 inhibitors, sitagliptin, saxagliptin and linagliptin, and other GLP-1 analogues such as exenatide, which are also discussed in LiverTox.

References regarding the hepatotoxicity and safety of liraglutide are given with the Overview section of the GLP-1 Analogues.

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Albiglutide, Dulaglutide, Exenatide, Lixisenatide, Semaglutide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Liraglutide – Victoza®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Liraglutide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Liraglutide | 204656-20-2 | Protein | Complex Polypeptide

## OTHER REFERENCE LINKS

1. Recent References on Liraglutide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Liraglutide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Liraglutide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Liraglutide)